# Heparins

## OVERVIEW

Heparin is a naturally occurring, complex glycosaminoglycan that has anticoagulant activity and has been used for decades as an antithrombotic agent in management of patients at high risk for thromboses. Heparin is synthesized in mast cells as a polymer from glucuronic acid and glucosamine residues, 10 to 15 of which are attached to a core protein resulting in a large proteoglycan of 750,000 to 1,000,000 daltons. This complex is then modified extensively and then degraded into glycosaminoglycan chains of 5000 to 30,000 daltons. Heparin for therapeutic use in humans is generally made from extracts of bovine lung or porcine intestinal mucosa and consists of a heterogeneous mixture of glycosaminoglycans of slightly different structures and molecular weights. Commercial preparations of heparin are standardized as USP units/mg.

Low molecular weight heparins (1000 to 10,000 daltons) are isolated from standard heparin preparations, which are then partially depolymerized and purified by gel chromatography and alcohol precipitation. Commercial preparations of low molecular weight heparins are standardized in a bioassay based upon inhibition of coagulation factor Xa. Heparin is a large glycosaminoglycan and is not absorbed through the gastrointestinal mucosa and must be given intravenously or by subcutaneous injection. Heparin is used as the initial treatment of venous thrombosis and pulmonary embolism because of its rapid onset of action, while awaiting the slower onset of activity of oral anticoagulants (such as warfarin). Heparin is also used in the setting of acute myocardial infarction and unstable angina and in prophylaxis of venous thrombosis during and/or after surgery. In addition, heparin is used to maintain patency of intravenous indwelling catheters (“heparin lock”), usually in low doses (10 to 100 units), and is not meant for therapeutic purposes. Recently, low molecular weight heparins have replaced standard heparin in many situations, their advantage being a more predictable pharmacokinetics which allows for subcutaneous administration and outpatient management.

The major side effects of heparin therapy are related to excessive bleeding and anticoagulation. However, heparin (both standard and low molecular weight forms) also has somewhat idiosyncratic side effects which includes hypersensitivity reactions, thrombocytopenia and serum enzyme elevations. Indeed, a large proportion of patients given standard or low molecular weight heparin intravenously develop serum ALT and AST elevations arising after 4 to 8 days of therapy that are usually asymptomatic and self-limited, lasting only 4 to 20 days and resolving sometimes even with continuation of treatment. The cause of these elevations is not known, but they are rarely associated with any symptoms. Serum alkaline phosphatase levels are elevated in a small proportion of cases but bilirubin levels are rarely above normal. For obvious reasons, the liver histological changes accompanying the aminotransferase elevations during heparin therapy has not been described.

The following agents are discussed separately, with references for all Heparin agents provided below.

Drug Class: Antithrombotic Agents, Anticoagulants

Drugs in the Subclass, Heparins: Heparin, Dalteparin, Enoxaparin, Tinzaparin

## ANNOTATED BIBLIOGRAPHY

References updated: 13 November 2017

Zimmerman HJ. Heparin. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999 mentions that heparin is reported to cause mildly increased aminotransferase levels in more than 80% of patients usually in the first 2 weeks).
Bhardwaj SS, Chalasani NP. Anticoagulants. Cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 608-11. (Review of hepatotoxicity of anticoagulants published in 2007 mentions that clinically apparent liver injury due to heparin is rare, but laboratory abnormalities are common, ALT levels >3 times ULN occur in 5% of patients).
Weitz JI. Blood coagulation and anticoagulant, thrombolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Sonnenblick M, Oren A, Jacobsonn W. Hyper-transaminasemia with heparin therapy. Br Med J 1975; 3: 77. (Among 14 patients given heparin [10,000 U every 6 hours for 10 days], 10 had transient [7-12 days] elevations in ALT [40-235 U/L] or AST [65-95 U/L] 3 to 15 days after starting and resolving in all with stopping; not accompanied by symptoms or increases in bilirubin or Alk P levels). 1139236
Bar-Or D, Gutman A. Proceedings: Effect of heparin administration on serum enzyme activities. Isr J Med Sci 1975; 11: 1225. (Abstract describing a study in rats showing that 25 to 50 units of heparin caused increases in AST from 53 [time 0] to 91 [1 hour] to a maximum of 214 U/L [9 hours] with similar increases in ALT). 1205827
Olsson R, Korsan-Bengtsen BM, Korsan-Bengtsen K, Lennartsson J, Waldenström. Serum aminotransferases after low-dose heparin treatment. Short communication. Acta Med Scand 1978; 204: 229-30. (Elevations in ALT, AST and LDH without Alk P or CPK elevations occurred in 4 of 13 patients and 8 of 9 healthy volunteers given heparin [5000 U every 8 hours] for 10 to 20 days, arising between day 4 and 8 and lasting for 4 to 16 days). 696422
Minar E, Ehringer H, Hirschl M, Ingerle H, Konecny U, Marosi L, Endler T, et al. [Transaminase increase: a largely unknown side-effect of heparin treatment (author's transl)]. Dtsch Med Wochenschr 1980; 105: 1713-7. German. (Among 46 patients treated with heparin [5000 to 15000 U every 8 hours], ALT or AST [without bilirubin or Alk P] elevations occurred in 89%, peaking early and then falling to baseline despite continuation of heparin; some correlation with heparin dosage). 6108201
Saffle JR, Russo J Jr, Dukes GE Jr, Warden GD. The effect of low-dose heparin therapy on serum platelet and transaminase levels. J Surg Res 1980; 28: 297-305. (Among 33 volunteers receiving standard heparin [5000 U every 12 hours for 10 days], ALT [45-287 U/L] elevations occurred in 62%, with peak values at day 11 and fall to normal within one week of stopping; Alk P and bilirubin values did not change; more frequent with porcine than bovine heparin and accompanied slight decline in platelet counts). 7366189
Shilo S, Abraham AS, Breuer R, Sonnenblick M. Hypertransaminasemia with subcutaneous heparin therapy. Isr J Med Sci 1981; 17: 1133-5. (Among 41 patients receiving low dose subcutaneous heparin after myocardial infarction or stroke, 16 had ALT or AST elevations, usually starting after 6 days and persisting for duration of treatment which did not occur in similar patients not on heparin). 7327913
Capuano G, Rodinò S, D'Agostino L, Budillon G. Evaluation of heparin toxicity in the isolated and perfused rat liver. Enzyme 1986; 35: 77-81. (Infusion of rats with human heparin resulted in no increase in serum ALT or AST and no change in bile production). 3743526
Dukes GE Jr, Sanders SW, Russo J Jr, Swenson E, Burnakis TG, Saffle JR, Warden GD. Transaminase elevations in patients receiving bovine or porcine heparin. Ann Intern Med 1984; 100: 646-50. (Among 86 patients followed prospectively, 59% developed ALT and 27% AST elevations during heparin therapy, averaging a 3.6-fold increase of ALT and 3.1-fold increase of AST, independent of source of heparin, but trending higher with higher doses and in men). 6712030
Husted SE, Nielsen HK, Koopmann HD, Fasting H, Simonsen O, Andersen K, Husegaard HC, et al. [Heparin-induced increase in serum aminotransferase]. Ugeskr Laeger 1984; 146: 647-9. Danish. 6710648
Nielsen HK, Husted SE, Koopmann HD, Fasting H, Simonsen O, Andersen K, Husegaard HC, et al. Heparin-induced increase in serum levels of aminotransferases. A controlled clinical trial. Acta Med Scand 1984; 215: 231-3. (64 patients were treated with low dose heparin [5000 U every 12 hours] or thromboembolic deterrent [TED] stockings after elective surgery; ALT levels were increased on the 5th and 10th day in the heparin group [mean rising from 27 to 40 to 55 U/L], but with no change in the TED stocking group). 6375273
Bratt G, Törnebohm E, Granqvist S, Aberg W, Lockner D. A comparison between low molecular weight heparin (KABI 2165) and standard heparin in the intravenous treatment of deep venous thrombosis. Thromb Haemost 1985; 54: 813-7. (Among 54 patients treated with either standard or low molecular weight heparin, mean serum ALT and AST values increased transiently with both forms to a similar degree). 3911482
Fareed J, Walenga JM, Williamson K, Emanuele RM, Kumar A, Hoppensteadt DA. Studies on the antithrombotic effects and pharmacokinetics of heparin fractions and fragments. Semin Thromb Hemost 1985; 11: 56-74. (Extensive analysis of antithrombotic effects of different forms of heparin). 3883500
Schwartz KA, Royer G, Kaufman DB, Penner JA. Complications of heparin administration in normal individuals. Am J Hematol 1985; 19: 355-63. (Among 40 male prison volunteers given porcine or bovine heparin [100 U/Kg every 6 hours] or saline for 10 days, all on heparin developed a reversible increase in ALT or AST starting by day 5 and continuing to day 10, with normal direct and total bilirubin, Alk P and CPK; one-third also had a reversible decrease in platelet counts). 4025314
Lambert M, Laterre PF, Leroy C, Lavenne E, Coche E, Moriau M. Modifications of liver enzymes during heparin therapy. Acta Clin Belg 1986; 41: 307-10. (In a retrospective study, 11 patients on continuous intravenous heparin [mean daily dose 31,500 U for 12 days] had elevations in serum ALT [averaging 3.9 times baseline], peaking 8 days after starting compared to elevations of 3 times baseline in 11 patients on subcutaneous heparin [mean dose 25,250 U for 10 days]). 2881417
Yurdakök M, Tanyel C, Diker S. Heparin-induced increase in serum levels of aminotransferases. Am J Hematol 1986; 22: 443. (Letter in response to Schwartz [1985] reporting elevations in AST and ALT 1 hour after intraperitoneal injection of heparin [5000 U] into kittens, but liver histology was normal). 3728459
Monreal M, Lafoz E, Salvador R, Roncales J, Navarro A. Adverse effects of three different forms of heparin therapy: thrombocytopenia, increased transaminases, and hyperkalaemia. Eur J Clin Pharmacol 1989; 37: 415-8. (Among 158 patients treated with heparin, ALT elevations occurred in 33% receiving high dose standard heparin [mean increase from 29 to 61 U/L], 17% on low dose [5000 U every 8 hours] standard heparin [from 27 to 49 U/L], and 3% on low dose [5000 U every 24 hours] low molecular weight heparin [from 26 to 29 U/L] for 8 days). 2557219
Freedman MD, Leese P, Prasad R, Hayden D. An evaluation of the biological response to Fraxiparine (a low molecular weight heparin) in the healthy individual. J Clin Pharmacol 1990; 30: 720-7. (Among 68 volunteers receiving different doses of a standard or low molecular weight heparin [fraxiparine], those treated with the higher doses of fraxiparine had 3-4 fold ALT elevations similar to those with standard heparin, arising by day 8 and falling to baseline by 10 days after dosing). 2169488
Olsson R, Leonhardt T. Cholestatic liver reaction during heparin therapy. J Intern Med. 1991; 229: 471-3. (3 patients developed abnormal liver tests after 7-12 days of heparin therapy [ALT 8.7-21 times ULN, Alk P 1.8-6.4 times ULN] without changes in bilirubin, resolving within 10-20 days of stopping). 2040875
Freedman MD. Low molecular weight heparins: an emerging new class of glycosaminoglycan antithrombotics. J Clin Pharmacol 1991; 31: 298-306. (Review of history, chemistry, pharmacokinetics, clinical efficacy and safety of low molecular weight heparins; the magnitude of ALT elevations appears to be less than with standard heparins). 1645375
Christiansen HM, Lassen MR, Borris LC, Sørensen JV, Rahr HB, Jørgensen LN, Jørgensen PW, Hauch O. Biologic tolerance of two different low molecular weight heparins. Semin Thromb Hemost 1991; 17: 450-4. (Among 219 patients treated with two low molecular weight heparins for up to 21 days, ALT, AST, LDH, Alk P and CPK values rose in both groups, becoming abnormal in 14-36% of subjects). 1666460
Buckley MM, Sorkin EM. Enoxaparin. A review of its pharmacology and clinical applications in the prevention and treatment of thromboembolic disorders. Drugs 1992; 44: 465-97. (Extensive review of the chemistry, pharmacology, clinical efficacy and safety of enoxaparin, a low molecular weight heparin). 1382939
Guevara A, Labarca J, González-Martin G. Heparin-induced transaminase elevations: a prospective study. Int J Clin Pharmacol Ther Toxicol 1993; 31: 137-41. (Among 54 patients who were treated with heparin and tested for ALT levels at least once during therapy, 8 [15%] developed an ALT elevation). 8468111
Spiro TE, Johnson GJ, Christie MJ, Lyons RM, MacFarlane DE, Blasier RB, Tremaine MD. Efficacy and safety of enoxaparin to prevent deep venous thrombosis after hip replacement surgery. Enoxaparin Clinical Trial Group. Ann Intern Med 1994; 121: 81-9. (Controlled trial of 7 day courses of one of 3 doses of enoxaparin as prevention of deep venous thrombosis in 572 patients undergoing hip replacement; ALT elevations of 3 times ULN occurred in 2-7% of patients, but all were reversible). 8017740
Pipek R, Avizohar O, Levy Y. Transient hepatic dysfunction in two brothers receiving heparin and streptokinase: a genetic predisposition? Int J Cardiol 1994; 46: 299-301. (Two brothers with acute myocardial infarction developed ALT elevations within 3 days of starting heparin and streptokinase infusions [ALT 320 and 4309 U/L], with normal bilirubin and Alk P levels and rapid recovery). 7814188
Tison T, Dazzi F, Vianello F, Radossi P, Girolami A. Marked but transitory elevation of hepatic transaminases after subcutaneous calcium heparin administration. Acta Haematol 1994; 92: 54. (70 year old woman with acute myocardial infarction developed ALT [839 U/L], LDH [1339 U/L] and bilirubin [2.1 mg/dL] elevations after a day of heparin therapy [7500 U every 8 hours], values falling rapidly upon stopping and returning to normal within 15 days). 7985487
Toulemonde F, Kher A. [Heparins and transaminases: an enigma without importance in 1994?]. Therapie 1994; 49: 356-8. (Discussion of phenomenon of ALT and AST elevations during heparin therapy and their lack of clinical significance). 7878605
Howard PA. Dalteparin: a low-molecular-weight heparin. Ann Pharmacother 1997; 31: 192-203. (Review of structure, pharmacology, efficacy and safety of dalteparin, the second low molecular weight heparin to be approved for use in the United States; no discussion of hepatotoxicity). 9034422
Martineau P, Tawil N. Low-molecular-weight heparins in the treatment of deep-vein thrombosis. Ann Pharmacother 1998; 32: 588-98, 601. (Review of studies comparing four forms of low molecular weight heparin, dalteparin, enoxaparin, nadroparin and tinzaparin for efficacy and safety; no discussion of ALT elevations or hepatotoxicity). 9606481
Barreiro López B, Canet JJ, Ochoa de Echaguen Aguilar A. [Liver toxicity from heparin]. An Med Interna 2000; 17: 164. Spanish. (67 year old man developed liver test abnormalities 8 days after starting heparin for suspected pulmonary embolus [ALT 512 U/L], with no jaundice or symptoms and rapid recovery on stopping). 10804648
Manfredini R, Boari B, Regoli F, Gallerani M. Cholestatic liver reaction and heparin therapy. Arch Intern Med 2000; 160: 3166. (54 year old man was found to have elevations in ALT [647 U/L] and Alk P [558 U/L] 3 days after starting heparin, persisting for duration of therapy and resolving over next 1-3 months). 11074748
AL-Mekhaizeem KA, Sherker AH. Heparin-induced hepatotoxicity. Can J Gastroenterol 2001; 15: 527-30. (Two cases: 83 year old man with unstable angina developed asymptomatic elevations in ALT [405 U/L], AST [635 U/L] and LDH [958 U/L] while on heparin, resolving within 3 days of stopping; 80 year old woman had marked elevations in ALT [762 U/L], AST [881 U/L] and LDH [958 U/L] within 8 hours of starting heparin, resolving within 4 hours of stopping). 11544537
Carlson MK, Gleason PP, Sen S. Elevation of hepatic transaminases after enoxaparin use: case report and review of unfractionated and low-molecular-weight heparin-induced hepatotoxicity. Pharmacotherapy 2001; 21: 108-13. (66 year old woman with deep venous thrombosis developed abdominal pain and elevations in ALT [147 U/L] and AST [93 U/L] 7 days after starting enoxaparin and warfarin, resolving within 3 weeks of stopping). 11191729
Hui CK, Yuen MF, Ng IO, Tsang KW, Fong GC, Lai CL. Low molecular weight heparin-induced liver toxicity. J Clin Pharmacol 2001; 41: 691-4. (26 year old woman developed serum enzyme elevations 4 days after starting enoxaparin [bilirubin normal, ALT 143 U/L, Alk P 313 U/L], which continued during treatment and reappeared with retreatment; 33 year old man developed enzyme elevations 5 days after starting fraxiparin [ALT 89 to 283 U/L, Alk P 65 U/L], resolving one month later). 11402639
Neely JL, Carlson SS, Lenhart SE. Tinzaparin sodium: a low-molecular-weight heparin. Am J Health Syst Pharm 2002; 59: 1426-36. (Review of structure, pharmacology, efficacy and safety of tinzaparin, a low molecular weight heparin; AST elevations occurred in 9% and ALT in 13% of patients in controlled trials of tinzaparin). 12166042
Reiter M, Bucek RA, Koca N, Heger J, Minar E; PERSIST. Idraparinux and liver enzymes: observations from the PERSIST trial. Blood Coagul Fibrinolysis 2003; 14: 61-5. (Among 37 patients followed prospectively, serum ALT, AST and GGT levels increased during a preliminary 4-7 day course of enoxaparin, but decreased into the normal range when patients were switched to idraparinux). 12544730
Fiessinger JN, Huisman MV, Davidson BL, Bounameaux H, Francis CW, Eriksson H, Lundström T, et al.; THRIVE Treatment Study Investigators. Ximelagatran vs low-molecular-weight heparin and warfarin for the treatment of deep vein thrombosis: a randomized trial. JAMA 2005; 293: 681-9. (Controlled trial of ximelagatran versus enoxaparin and warfarin in 2489 patients with deep vein thromboses, ALT elevations above 3 times ULN occurred in 9.6% of ximelagatran vs 2% of enoxaparin/warfarin treated patients, and at least one patient on ximelagatran developed clinically apparent liver injury). 15701909
Agnelli G, Bergqvist D, Cohen AT, Gallus AS, Gent M; PEGASUS investigators. Randomized clinical trial of postoperative fondaparinux versus perioperative dalteparin for prevention of venous thromboembolism in high-risk abdominal surgery. Br J Surg 2005; 92: 1212-20. (Among 2048 patients treated with fondaparinux or dalteparin for 5 to 9 days, side effects were similar in the two groups; no discussion of liver injury or ALT elevations). 16175516
Turpie AG. The safety of fondaparinux for the prevention and treatment of venous thromboembolism. Expert Opin Drug Saf 2005; 4: 707-21. (Review of clinical efficacy and safety of fondaparinux; ALT elevations above 3 times the ULN occurred in 1.3-2.6% of patients on fondaparinux compared to 0.7% on placebo, 3.9-12.3% on enoxaparin, and 8% on heparin; abnormalities were usually asymptomatic and not associated with bilirubin elevations). 16011449
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to heparin, low molecular weight heparins or other anticoagulants). 18955056
Baker EL, Loewenthal T, Salerno E, Baker WL. Probable enoxaparin-induced hepatotoxicity. Am J Health Syst Pharm 2009; 66: 638-41. (29 year old woman developed nausea and serum enzyme elevations within 2 days of starting enoxaparin [bilirubin 0.6-0.8 mg/dL, ALT 321 to 465 U/L, Alk P 117-194 U/L], symptoms resolving within 2 days and liver tests within 3 months of stopping). 19299370
Hoy SM, Scott LJ, Plosker GL. Tinzaparin sodium: a review of its use in the prevention and treatment of deep vein thrombosis and pulmonary embolism, and in the prevention of clotting in the extracorporeal circuit during haemodialysis. Drugs 2010; 70: 1319-47. (Review of structure, pharmacology, efficacy and safety of tinzaparin, a low molecular weight heparin; there were statistically significant elevations in serum aminotransferase levels in tinzaparin treated patients, but the mean levels of ALT and AST remained within the normal range). 20568836
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, but none were due to anticoagulants or heparins). 20949552
Watkins PB, Desai M, Berkowitz SD, Peters G, Horsmans Y, Larrey D, Maddrey W. Evaluation of drug-induced serious hepatotoxicity (eDISH): application of this data organization approach to phase III clinical trials of rivaroxaban after total hip or knee replacement surgery. Drug Saf 2011; 34: 243-52. (Analysis of 4 controlled trials of anticoagulation in 12,262 subjects identified ALT elevations >3 times ULN without bilirubin elevations in 143 [2.3%] rivaroxaban and 223 [3.6%] enoxaparin recipients, and combined ALT and bilirubin increases in only 8-9 patients in each treatment arm [~0.15%], but other causes accounted for most). 21332248
Harrill AH, Roach J, Fier I, Eaddy JS, Kurtz CL, Antoine DJ, Spencer DM, et al. The effects of heparins on the liver: application of mechanistic serum biomarkers in a randomized study in healthy volunteers. Clin Pharmacol Ther 2012; 92: 214-20. (Among 48 healthy volunteers who received subcutaneous heparin, enoxaparin, dalteparin or adomiparin for 4.5 days, asymptomatic elevations of ALT elevations rose in 94%, beginning to rise on day 3 and peaking [1 to 13 times ULN] at day 7 and falling to near baseline within the next week; other markers of liver injury including glutamate dehydrogenase, miR-122, full length keratin 18 and high mobility group box-1 protein also increased while serum Alk P and bilirubin levels remained unchanged). 22739141
Levinson P, Glaumann H, Söderberg M. Probable dalteparin-induced hepatotoxicity in a man with alpha-1-antitrypsin deficiency. J Clin Pharmacol 2012; 52: 1764-7. (52 year old man with emphysema and alpha-1-antitrypsin deficiency developed serum enzyme elevations 5 days after starting dalteparin, which was continued and he developed fever and jaundice after 4 weeks of treatment [bilirubin 6.0 mg/dL, ALT 457 U/L, Alk P 281 U/L], resolving within 4 weeks of stopping). 22167567
Levinson P, Glaumann H, Söderberg M. [Toxic hepatitis most likely triggered by dalteparin]. Lakartidningen 2013; 110: 1348-9. Swedish. (Same case as in Levinson [2012], but in Swedish). 23980446
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to enoxaparin, but no details given). 23419359
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart 2014; 100: 550-6. (Systematic review of the literature on liver injury due to new oral anticoagulants reported results from 25 studies showing no increase in the risk of serum aminotransferase elevations with new agents [dabigatran, apixaban, darexaban, edoxaban and rivaroxaban] compared to controls [usually low molecular weight heparins]). 24476812
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to heparins). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to dalteparin, but none to the other heparins). 25754159
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 patients with hepatitis of unknown cause who were inpatients at 51 hospitals in Berlin and enrolled in a prospective case control study between 2002 and 2011, heparin was being administered to 17 of 76 cases [22%] vs 38 of 377 controls [10%] and enoxapain to 20 of 76 cases [26%] vs 67 [18%] controls, but neither difference was statistically significant). 25444550
Hahn KJ, Morales SJ, Lewis JH. Enoxaparin-induced liver injury: case report and review of the literature and FDA adverse event reporting system (FAERS). Drug Saf Case Rep 2015; 2: 17. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27747729) (45 year old man developed asymptomatic ALT elevations 4 days after starting enoxaparin [bilirubin 0.7 mg/dL, ALT 579 peaking at 770 U/L, Alk P 104 peaking at 119 U/L], ALT levels falling to near normal within 2 weeks of stopping and switching to fondaparinux).

## OTHER REFERENCE LINKS

1. Recent References on Heparins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Heparins/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Heparins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Heparins)